# Sulfasalazine

## OVERVIEW

### Introduction

Sulfasalazine is an antiinflammatory agent used often in combination with other agents in the chronic, long-term therapy of inflammatory bowel disease. Sulfasalazine is structurally composed of a sulfonamide (sulfapyridine) and 5-aminosalacyclic acid (5-ASA) joined by an azo bond. Sulfasalazine is a rare, but well-known cause of clinically apparent idiosyncratic liver injury.

### Background

Sulfasalazine (sul" fa sal’ a zine) is a modified sulfonamide composed of sulfapyridine that is covalently linked to 5-aminosalacyclic acid (5-ASA). Sulfasalazine is poorly absorbed from the upper intestine, but its azo bond is broken by bacteria in the lower intestinal bowel lumen releasing sulfapyridine that is absorbed and 5-ASA, which reaches high levels and acts locally decreasing intestinal inflammation. Sulfasalazine was approved for clinical use in the United States in 1950 and is still used. Current indications are for treatment of active ulcerative colitis and prevention of relapses, both in adults and children. Sulfasalazine is also used for juvenile idiopathic and adult rheumatoid arthritis. Sulfasalazine is available in generic forms in 500 mg tablets and under the commercial name Azulfidine. Both immediate and extended-release forms are available, both of which are used in ulcerative colitis. In contrast, only the extended-release forms are recommended for inflammatory arthritis. The usual dose in adults is 3 to 4 grams daily initially, with maintenance dosage of 2 grams daily (4 divided doses). Common side effects include anorexia, headache, nausea, vomiting, gastrointestinal upset, fever, arthralgias and rash. Serious side effects include low sperm count, hypersensitivity reactions, severe cutaneous adverse reactions [SCAR] such as Stevens Johnson syndrome, toxic epidermal necrosis, and drug reaction with eosinophilia and systemic symptoms (DRESS syndrome), liver and kidney injury and blood dyscrasias.

### Hepatotoxicity

Sulfasalazine, like other sulfonamides, can cause a characteristic idiosyncratic liver injury that has features of drug-allergy or hypersensitivity. The presentation, course, and outcome of sulfasalazine associated liver injury varies greatly. The typical onset is sudden development of fever and rash followed by jaundice a few days or weeks later. The latency to onset is usually 2 to 6 weeks and is rarely more than 8 weeks after starting therapy. Shorter latencies can be seen with re-exposures. At least half of cases are accompanied by allergic manifestations such as rash, fever, lymphadenopathy, facial edema, eosinophilia, and atypical lymphocytosis. These features of hypersensitivity may precede the hepatic manifestations but in other cases arise days or weeks after initial presentation with symptoms of liver disease. The pattern of injury is most often mixed, but it can be markedly cholestatic or markedly hepatocellular. For unknown reasons, injury in children and young adults is more often hepatocellular, while cholestatic cases occur more frequently in the elderly. The course of the liver injury may be short-lived with rapid recovery or complicated and prolonged. Cases with cholestatic sulfasalazine related liver injury are often prolonged and some are accompanied by varying degrees of bile duct injury and loss leading to vanishing bile duct syndrome and chronic cholestasis which, if severe, can lead to biliary cirrhosis, chronic liver failure, and death or need for liver transplantation. However, vanishing bile duct syndrome usually improves spontaneously over time, with gradual resolution of jaundice and symptoms, leaving minor alkaline phosphatase and GGT elevations may persist for years.

Sulfasalazine is a well-known cause of drug-reaction with eosinophilia and systemic symptoms (DRESS) syndrome. At least 75% of such cases are associated with some degree of liver injury, usually with only transient and minor elevations of liver related enzymes, but sometimes with moderate or severe liver injury. Finally, rare instances of Stevens Johnson syndrome (SJS) and toxic epidermal necrosis (TEN) have been linked to sulfasalazine therapy. Liver injury is not uncommon with these severe cutaneous reactions, but the liver abnormalities are usually overshadowed by the cutaneous manifestations.

Hepatocellular forms of sulfasalazine vary greatly in severity from asymptomatic aminotransferase elevations to acute hepatitis with jaundice to cases of acute liver failure leading to death or emergency liver transplantation. The fatality rate of sulfasalazine induced acute hepatocellular injury accompanied by jaundice (so called “Hy’s Law cases”) is at least 10%. Nevertheless, most cases of sulfasalazine liver injury resolve rapidly once the medication is withdrawn, usually within 2 to 4 weeks unless cholestasis is severe.

Because sulfasalazine is given chronically, rare instances of late onset of drug induced liver disease have been reported, but the characteristic signature and pattern of injury is different from typical sulfasalazine injury, and the role of other medications or an underlying autoimmune condition in these late onset cases has yet to be resolved. Chronic therapy may also be associated with mild and transient ALT elevations either alone or as a part of a generalized hypersensitivity reaction. Acute hypersensitivity reactions from many medications can be accompanied by granulomas in the liver, but also in the skin, lymph nodes, and other internal organs.

Likelihood score: A (well established cause of clinically apparent acute liver injury)

### Mechanism of Injury

The clinical pattern of injury with sulfasalazine suggests a drug-allergy or hypersensitivity mechanism, perhaps through the metabolism of the sulfonamide component to a toxic, reactive or antigenic metabolite. Sulfasalazine associated DRESS syndrome has been linked to HLA-B*13:01 in a large series from China. In large series on DRESS syndrome, sulfasalazine has .

The other component of sulfasalazine is 5-aminosalicyclic acid (5-ASA) with can also cause idiosyncratic liver injury, but far less commonly. 5-ASA is active locally in the large intestine and plasma levels are not very high.

### Outcome and Management

Sulfasalazine induced liver injury can result in minor ALT and alkaline phosphatase elevations (sometimes with other signs of hypersensitivity and with hepatic granulomas), acute self-limited hepatitis and even acute liver failure. Most cases resolve rapidly with discontinuation of drug, and full recovery is expected within 2 to 8 weeks. Cases with rash, fever, and other signs of hypersensitivity often treated with a short course of corticosteroids, which appears to shorten the duration of signs and symptoms but has not been shown to change the ultimate outcome of hepatic injury. Corticosteroids do not appear to benefit cholestatic injury without allergic or hypersensitivity manifestations and demonstrate no evidence of benefit for the vanishing bile duct syndrome.

Importantly, rechallenge should not be done, and patients should be told that they are allergic to sulfonamides (“sulfa-drugs”) and should not receive other drugs in this class. The other component of sulfasalazine is 5-aminosalicyclic acid (5-ASA) with can also cause idiosyncratic liver injury. Prednisone has been used with variable success but may be particularly helpful in patients with prominent allergic features with systemic features and fever, severe rash, arthralgias, lymphadenopathy, facial edema, and eosinophilia or atypical lymphocytosis. There are rare reports of recurrence of similar but mild injury after switching from sulfasalazine to products with 5-ASA alone such as mesalamine. But there is no evidence of cross sensitivity to hepatic injury with most other biologic or small molecule drugs used to treat ulcerative colitis or rheumatoid arthritis.

Drug Class: Antiinfective Agents, Sulfonamides

Other agents in this subclass: Dapsone, Sulfadiazine, Sulfadoxine- Pyrimethamine, Sulfamethoxazole-Trimethoprim, Sulfasalazine, Sulfinpyrazone, Sulfisoxazole

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Sulfasalazine – Generic, Azulfidine®

DRUG CLASS

Antiinfective Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=sulfasalazine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO | MOLECULAR FORMULA | STRUCTURE
Sulfasalazine | 599-79-1 | C18-H14-N4-O5-S

## ANNOTATED BIBLIOGRAPHY

References updated: 10 January 2025

Abbreviations: TMP/SMZ, trimethoprim and sulfamethoxazole

Zimmerman HJ. Sulfonamides. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 606-9. (Expert review of the sulfonamides and sulfones published in 1999; sulfonamides are thought to cause clinically apparent liver injury in 0.5-1.0% of recipients generally with a sudden onset within 14 days of starting, often with immunoallergic features and a hepatocellular or mixed pattern of injury; mortality may be as high as 10%).
Moseley RH. Sulfonamides. Hepatotoxicity of antimicrobials and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 463-82. (Review of hepatotoxicity of antibiotics including sulfonamides).
MacDougall C. Sulfonamides, trimethoprim-sulfamethoxazole, quinolones, and agents for urinary tract infections. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1011-1021. (Textbook of pharmacology and therapeutics).
MacNaughton WK, Sharkey KA. Pharmacotherapy of inflammatory bowel disease. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 945-954. (Textbook of pharmacology and therapeutics).
Das KM, Eastwood MA, McManus JP, Sircus W. Adverse reactions during salicylazosulfapyridine therapy and the relation with drug metabolism and acetylator phenotype. N Engl J Med 1973; 289: 491-5. (Slow acetylators of sulfapyridine were more likely to have side effects and high serum levels). 4146729
Rafoth RJ. Systemic granulomatous reaction to salicylazosulfapyridine (Azulfidine) in a patient with Crohn's disease. Am J Dig Dis 1974; 19: 465-9. (35 year old woman developed Stevens Johnson syndrome with minimal Alk P elevations, peak bilirubin 1.8 mg/dL, 19 days after starting sulfasalazine [Azulfidine]; liver and lymph node biopsies showed granulomas). 4151115
Chester AC, Diamond LH, Schreiner GE. Hypersensitivity to salicylazosulfapyridine: renal and hepatic toxic reactions. Arch Intern Med 1978; 138: 1138-9. PMID: 27155 (19 year old woman developed fever, rash, eosinophilia, adenopathy and jaundice arising 3 weeks after starting sulfasalazine [bilirubin 6.5 mg/dL, AST 1060 U/L], with accompanying nephritis, resolving after 2 weeks of prednisone).
Callen JP, Soderstrom RM. Granulomatous hepatitis associated with salicylazosulfapyridine therapy. South Med J 1978; 71: 1159-60. PMID: 28568 (36 year old woman developed drug-fever on sulfasalazine with minimal ALT elevations and granulomas on liver biopsy that resolved with discontinuation of drug, follow up biopsy was normal).
Sotolongo RP, Neefe LI, Rudzki C, Ishak KG. Hypersensitivity reaction to sulfasalazine with severe hepatotoxicity. Gastroenterology 1978; 75: 95-9. PMID: 45581 (19 year old woman developed nausea 2 weeks after starting sulfasalazine for inflammatory bowel disease followed by fever and rash [bilirubin 0.8 rising to 5.6 mg/dL, AST 109 U/L, Alk P 322 U/L. 10% eosinophils], treated with prednisolone and recovered in 1 month).
Jacobs E, Paulet P, Rahier J. Hypersensitivity reaction to sulfasalazine--another case. Gastroenterology 1978; 75: 1193. PMID: 30678 (19 year old female with Crohn disease developed jaundice with high ALT levels, rash, fever, eosinophilia and lymphadenopathy after 8 weeks of sulfasalazine therapy, resolving within 4 weeks).
Kanner RS, Tedesco FJ, Kalser MH. Azulfidine- (sulfasalazine-) induced hepatic injury. Am J Dig Dis 1978; 23: 956-8. PMID: 31085 (13 year old girl developed fever, rash, eosinophilia, lymphadenopathy and atypical lymphocytosis 3 weeks after starting sulfasalazine [bilirubin 4.1 mg/dL, AST 228 U/L, Alk P 149 U/L], rechallenge led to severe hepatocellular injury within 1 day).
Mihas AA, Goldenberg DJ, Slaughter RL. Sulfasalazine toxic reactions. Hepatitis, fever, and skin rash with hypocomplementemia and immune complexes. JAMA 1978; 239: 2590-1. PMID: PMID: 26816 (26 year old man developed jaundice, fever, rash, adenopathy, atypical lymphocytosis and systemic symptoms 3 weeks after starting sulfasalazine for Crohn disease [bilirubin 1.5 mg/dL, ALT 680 U/L, Alk P 680 U/L, 12% eosinophils], resolving by 12 weeks with prednisone).
Gulley RM, Mirza A, Kelly CE. Hepatotoxicity of salicylazosulfapyridine: a case report and review of the literature. Am J Gastroenterol 1979; 72: 561-4. PMID: 43669 (20 year old woman with Crohn disease developed fever 3 weeks after starting sulfasalazine accompanied by a mixed pattern of serum enzyme elevations without jaundice and had recurrence with a similar anicteric pattern 4 days after restarting).
Iwarson S, Lundin P. Multiple attacks of jaundice associated with repeated sulfonamide treatment. Acta Med Scand 1979; 206: 219-22. (Four women, ages 20, 30, 35 and 68 years, who had repeated episodes of liver injury after sulfonamides with shortening of latency upon re-exposure, but no worsening of injury [usually hepatocellular] or slowing of resolution, which ranged from 4-12 weeks). 495230
Losek JD, Werlin SL. Sulfasalazine hepatotoxicity. Am J Dis Child 1981; 135: 1070-2. (13 year old boy with Crohn disease developed fever and rash 11 days after starting sulfasalazine with subsequent marked rise in AST [1743 U/L], but normal bilirubin and rapid resolution; positive rechallenge to single dose with rash, fever and minimal ALT elevation within 1 day). 6117199
Namias A, Bhalotra R, Donowitz M. Reversible sulfasalazine-induced granulomatous hepatitis. J Clin Gastroenterol 1981; 3: 193-8. (25 year old man developed fever and jaundice [bilirubin rising to 4.0 mg/dL, ALT to ~775 U/L] 19 days after starting sulfasalazine, resolving within 6 weeks of stopping while on prednisone; liver biopsy showed granulomas). 6113258
Døssing M, Andreasen PB. Drug-induced liver disease in Denmark. An analysis of 572 cases of hepatotoxicity reported to the Danish Board of Adverse Reactions to Drugs. Scand J Gastroenterol 1982; 17: 205-11. (572 reports of drug induced liver injury from 1968-78 were analyzed, representing 6% of total adverse reaction reports and 12% of those that were fatal; halothane accounted for 25% of cases, chlorpromazine 9%, sulfonamides 9%, antituberculosis agents 7%, oxyphenisatin 4% and methyldopa 2%). 6982502
Larcan A, Lambert H, Janot C, Perarnaud J, Delorme N, Tonnel F. [Fatal hepatitis during sulfasalazine treatment] Therapie 1982; 37: 315-9. French. PMID: 6127817 (17 year old with Crohn disease developed rash, eosinophilia, and severe hepatocellular injury with jaundice [bilirubin 3.7 mg/dL, ALT 1050 U/L, Alk P 500 U/L] 3 weeks after starting sulfasalazine, progressing to acute liver failure and death).
Smith MD, Gibson GE, Rowland R. Combined hepatotoxicity and neurotoxicity following sulphasalazine administration. Aust N Z J Med 1982; 12: 76-80. (Two cases of hepatocellular injury arising 3 and 5 weeks after starting sulfasalazine with rash, fever, jaundice, and neurologic signs of confusion, hallucinations, and stiff neck; rapid recovery after stopping and with prednisone therapy). 6123306
Lennard TW, Farndon JR. Sulphasalazine hepatotoxicity after 15 years’ successful treatment for ulcerative colitis. Br Med J (Clin Res Ed) 1983; 287: 96. (37 year old man with ulcerative colitis developed asymptomatic elevations in Alk P [380 U/L] and AST [49 U/L] after 15 years of sulfasalazine use, with positive rechallenge, prednisone also used and issue of sclerosing cholangitis and autoimmune hepatitis not completely addressed). 6134567
Holdsworth CD. Sulphasalazine hepatotoxicity after 15 years' treatment. Br Med J (Clin Res Ed) 1983; 287: 759. (Letter in response to Lennard [1983] discussing possibility of sclerosing cholangitis in view of presence of ulcerative colitis). 6137258
Taffet SL, Das KM. Sulfasalazine. Adverse effects and desensitization. Dig Dis Sci 1983; 28: 833-42. (Review article on adverse effects of sulfasalazine with mention of 14 case reports of liver injury, 5 with positive rechallenge, some fatal and some with granulomas). 6136396
Fich A, Schwartz J, Braverman D, Zifroni A, Rachmilewitz D. Sulfasalazine hepatotoxicity. Am J Gastroenterol 1984; 79: 401-2. (Two cases: 52 year old woman and 32 year old man with inflammatory bowel disease had hypersensitivity reactions to sulfasalazine with ALT and Alk P elevations, but no jaundice, resolving with discontinuation). 6144268
Farr M, Symmons DP, Bacon PA. Raised serum alkaline phosphatase and aspartate transaminase levels in two rheumatoid patients treated with sulphasalazine. Ann Rheum Dis 1985; 44: 798-800. (Two women, ages 71 and 72 years, had marked Alk P elevations [745 and >2000 U/L] starting within 1 week of starting sulfasalazine for rheumatoid arthritis, without allergic manifestations, resolving slowly after stopping). 2865931
Haines JD Jr. Hepatotoxicity after treatment with sulfasalazine. Postgrad Med 1986; 79: 193-4, 197-8. (42 year old man with Crohn disease had onset of rash, fever, and abdominal pain 18 days after starting sulfasalazine followed by jaundice and progressive hepatic failure [ALT 3700 U/L, Alk P 619 U/L, bilirubin 18.4 mg/dL], leading to multiorgan failure and death; autopsy showed massive necrosis). 2871549
Jennings PE, Blandford RL, Rosenthal FD. Acute sulphasalazine hepatotoxicity. Postgrad Med J 1986; 62: 305-6. (37 year old man with severe hepatocellular injury [bilirubin 6.9 mg/dL, ALT 1994 U/L, Alk P 271 U/L] starting with rash 2 weeks after starting sulfasalazine, slow to resolve). 2872666
Labadie H, Beaugrand M, Ferrier JP. [Hepatitis and mononucleosis syndrome related to the ingestion of salazosulfapyridine]. Rev Med Interne 1986; 7: 35-40. French. PMID: 2871605 (25 year old developed fever and rash 7 days after starting sulfasalazine with atypical lymphocytosis, but negative EBV testing [bilirubin 1.5 mg/dL, ALT 1035 U/L, Alk P 250 U/L]).
MacGilchrist AJ, Hunter JA. Sulphasalazine hepatotoxicity: lack of a hypersensitivity response. Ann Rheum Dis 1986; 45: 967-8. (50 year old woman with rheumatoid arthritis developed anorexia and abdominal pain 11 weeks after starting sulfasalazine; no features of hypersensitivity [bilirubin normal, ALT 1449 U/L, Alk P 230 U/L], resolving within 17 days of stopping). 2878646
Poland GA, Love KR. Marked atypical lymphocytosis, hepatitis, and skin rash in sulfasalazine drug allergy. Am J Med 1986; 81: 707-8. (38 year old man developed rash, fever, myalgias, and facial edema with eosinophilia, atypical lymphocytosis and liver test abnormalities, within 2 weeks of starting sulfasalazine [bilirubin 2.8 mg/dL, ALT 202 U/L, Alk P 465 U/L], resolving rapidly with prednisone). 2876632
Ribe J, Benkov KJ, Thung SN, Shen SC, LeLeiko NS. Fatal massive hepatic necrosis: a probable hypersensitivity reaction to sulfasalazine. Am J Gastroenterol 1986; 81: 205-8. (15 year old boy developed severe hepatocellular injury and rash starting within 2 weeks of starting sulfasalazine, treated with prednisone and relapse of jaundice and rash when tapered; patient died of acute hemorrhage, probably from corticosteroids rather than hepatic injury). 2869683
Coumaros D, Georges C, Zerbe S. Salicylazosulfapyridine (SASP) hepatitis: role of 5-aminosalicylic acid (5-ASA). Scand J Gastroenterol 1989; 24 (suppl 158): 132-3. Not in PubMed (26 year old woman found to have elevated ALT [5.5 times ULN] 1 year after starting sulfasalazine, not resolving until both sulfonamide and 5-ASA were stopped).
Rachmilewitz D. Coated mesalazine (5-aminosalicylic acid) versus sulphasalazine in the treatment of active ulcerative colitis: a randomised trial. BMJ 1989; 298: 82-6. (In a multicenter controlled trial of 5-ASA [mesalazine] vs sulfasalazine in 164 patients, the two agents had similar efficacy, but there were fewer hypersensitivity effects with mesalazine; nevertheless, 3% of 5-ASA treated patients developed raised ALT values and one developed hepatitis with jaundice). 2563951
Brooks H, Taylor HG, Nichol FE. The three week sulphasalazine syndrome. Clin Rheumatol 1992; 11: 566-8. (53 year old man with rheumatoid arthritis developed fever, rash, atypical lymphocytes, eosinophilia, and low complement levels, similar to serum sickness 2 weeks after starting sulfasalazine [bilirubin 6.0 rising to 8.9 mg/dL, ALT 231 U/L, Alk P 706 U/L], with slow recovery despite corticosteroids). 1362531
Hautekeete ML, Bourgeois N, Potvin P, Duville L, Reynaert H, Devis G, Adler M, et al. Hypersensitivity with hepatotoxicity to mesalazine after hypersensitivity to sulfasalazine. Gastroenterology 1992; 103: 1925-7. (21 year old woman developed rash 3 weeks after starting sulfasalazine, recurring 1 day after starting mesalazine [5-ASA] alone [bilirubin 2.5 mg/dL, ALT 102 U/L, Alk P 560 U/L]; went on to develop liver failure, but ultimately survived). 1360436
Leroux JL, Ghezail M, Chertok P, Blotman F. Hypersensitivity reaction to sulfasalazine: skin rash, fever, hepatitis and activated lymphocytes. Clin Exp Rheumatol 1992; 10: 427. (45 year old woman with rheumatoid arthritis developed fever, rash and facial edema 3 weeks after starting sulfasalazine [bilirubin not given, ALT 39 U/L, Alk P 212 U/L, eosinophils 50%], with rapid recovery upon stopping). 1356682
Cribb AE, Pohl LR, Spielberg SP, Leeder JS. Patients with delayed-onset sulfonamide hypersensitivity reactions have antibodies recognizing endoplasmic reticulum luminal proteins. J Pharmacol Exp Ther 1997; 282: 1064-71. (Comprehensive review of the major and minor side effects of sulfonamides including discussion of mechanisms). 9262376
Stoschus B, Meybehm M, Spengler U, Scheurlen C, Sauerbruch T. Cholestasis associated with mesalazine therapy in a patient with Crohn's disease. J Hepatol 1997; 26: 425-8. (30 year old man developed nausea and jaundice 4 months after starting mesalazine [5-ASA] [bilirubin 6.0 mg/dL, ALT 393 U/L, Alk P 201 U/L]; no hypersensitivity features; resolving within 6 weeks of stopping therapy). 9059966
Besnard M, Debray D, Durand P, Cézard JP, Navarro J. Sulfasalazine-induced fulminant hepatitis in pediatric Crohn's disease: report of two cases. J Pediatr Gastroenterol Nutr 1998; 26: 119-20. (2 cases of 10 year olds [1 boy, 1 girl] developing fever, rash, arthralgias, and eosinophilia 2-3 weeks after starting sulfasalazine, both progressing to acute liver failure). 9443132
Deltenre P, Berson A, Marcellin P, Degott C, Biour M, Pessayre D. Mesalazine (5-aminosalicylic acid) induced chronic hepatitis. Gut 1999; 44: 886-8. (65 year old man developed elevated ALT levels [8-12 times ULN] without jaundice after 6 months of mesalazine therapy that continued for 10 months and was associated with autoantibodies [ANA 1:500, SMA 1:200] and chronic hepatitis on biopsy; resolved rapidly once drug was stopped). 10323894
Lau G, Kwan C, Chong SM. The 3-week sulphasalazine syndrome strikes again. Forensic Sci Int 2001; 122: 79-84. (34 year old woman developed fever, rash, and lymphadenopathy 17 days after starting sulfasalazine, with subsequent hepatocellular jaundice [bilirubin 8.9 mg/dL, ALT 10,000 U/L, Alk P 515 U/L], progressing to liver failure and death). 11672959
Ransford RA, Langman MJ. Sulphasalazine and mesalazine: serious adverse reactions re-evaluated on the basis of suspected adverse reaction reports to the Committee on Safety of Medicines. Gut 2002; 51: 536-9. (Survey of adverse drug reaction reporting on 5-ASA vs sulfasalazine – UK from 1991-8 – found sulfasalazine more commonly causes liver injury ~0.6 vs 0.32/100,000 exposures). 12235076
Sgro C, Clinard F, Ouazir K, Chanay H, Allard C, Guilleminet C, Lenoir C, et al. Incidence of drug-induced hepatic injuries: a French population-based study. Hepatology 2002; 36: 451-5. (All adverse drug reactions from French region from 1997-2000 found 34 cases of liver injury, 40 drugs involved, 2 possibly due to sulfasalazine). 12143055
Halmos B, Anastopoulos HT, Schnipper LE, Ballesteros E. Extreme lymphoplasmacytosis and hepatic failure associated with sulfasalazine hypersensitivity reaction and a concurrent EBV infection--case report and review of the literature. Ann Hematol 2004; 83: 242-6. (34 year old man with Crohn disease developed fever, rash, atypical lymphocytosis, and hepatic failure after 1 day of restarting sulfasalazine, [bilirubin rising from 4.0 to 10.4 mg/dL, AST 1628 U/L, 10% eosinophilia], with apparent beneficial response to prednisone). 13680174
Slatore CG, Tilles SA. Sulfonamide hypersensitivity. Immunol Allergy Clin North Am 2004; 24: 477-90, vii. PMID: 15242722 (Review of mechanisms of hypersensitivity to sulfonamides).
de Abajo FJ, Montero D, Madurga M, Rodriguez LAG. Acute and clinically relevant drug-induced liver injury: a population based case-control study. Brit J Clin Pharm 2004; 58: 71-80. (Analysis of General Practice Research Database from UK on 1.6 million persons from 1994-2000 found 128 cases of drug induced liver injury [2.4/100,000 person-years]; sulfasalazine was taken by 4 of 128 cases [3%], compared to 5 of 5000 controls [adjusted odds ratio 25.5]). 15206996
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants done in the US between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, 3 of which were attributed to sulfasalazine and 1 to TMP-SMZ). 15390328
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (Among 103 cases of fulminant drug induced liver injury reported to a Swedish registry between 1966 and 2002, 6 cases were attributed to TMP-SMZ, 3 to sulfonamides and 1 to sulfasalazine [~10% overall]). 16165719
Descloux E, Argaud L, Dumortier J, Scoazec JY, Boillot O, Robert D. Favourable issue of a fulminant hepatitis associated with sulfasalazine DRESS syndrome without liver transplantation. Intensive Care Med 2005; 31: 1727-8. (45 year old woman developed rash 15 days after starting sulfasalazine and subsequently developed fever, eosinophilia, and progressive liver injury leading to liver failure and death; autopsy showed massive necrosis). 16283166
Andrade RJ, Lucena MI, Fernández MC, Pelaez G, Pachkoria K, Garcia-Ruiz E, Garcia-Munoz B, et al.; Spanish Group for the Study of Drug-Induced Liver Disease. Drug-induced liver injury: an analysis of 461 incidences submitted to the Spanish registry over a 10-year period. Gastroenterology 2005; 129: 512-21. (Reports to a Spanish network between 1994-2004, included 461 cases of drug induced liver disease; sulfonamides were not mentioned in the top 19 causes [drugs with 5 or more cases]). 16083708
Garcia Rodriguez LA, Ruigomez A, Jick H. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-1101. (Among 103 cases of fulminant drug induced liver injury reported to a Swedish registry between 1966 and 2002, 6 cases were attributed to TMP-SMZ, 3 to sulfonamides and 1 to sulfasalazine [~10% overall]). 16165719
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (Survey of drug induced liver fatalities reported to WHO database between 1968-2003 revealed 4690 reports – 89% from the US; 21 drugs were associated with more than 50 cases each, including TMP-SMZ [ranking 10th]). 16054882
Teo L, Tan E. Sulphasalazine-induced DRESS. Singapore Med J. 2006; 47: 237-9. (49 year old woman developed purpuric rash and eosinophilia after 4 weeks of sulfasalazine therapy accompanied by serum enzyme elevations [ALT 171 U/L, Alk P 115 U/L] but no jaundice, rapidly resolving after stopping). 16518561
Jobanputra P, Amarasena R, Maggs F, Homer D, Bowman S, Rankin E, Filer A, Raza K, Jubb R. Hepatotoxicity associated with sulfasalazine in inflammatory arthritis: A case series from a local surveillance of serious adverse events. BMC Musculoskelet Disord 2008; 9: 48. (Ten cases of sulfasalazine hepatotoxicity identified in a UK rheumatology service over 7 year period; usual onset in 2-42 days, 7 with rash, 3 eosinophilia, 5 cases in blacks, two patients required liver transplantation; estimated frequency of 4 per thousand patients exposed). 18405372
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, et al; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 9 were due to TMP-SMZ, which ranked 4th as a cause). 18955056
Jobanputra P. BSR DMARD monitoring guidelines: sulfasalazine. Rheumatology (Oxford) 2008; 47:1587-8. (Letter in response to published guidelines on sulfasalazine stressing the severe, but rare complication of hepatitis [0.4%] which can lead to acute liver failure). 18723518
Björnsson E, Davidsdottir L. The long-term follow-up after idiosyncratic drug-induced liver injury with jaundice. J Hepatol 2009; 50: 511-7. (Among 685 patients identified an average of 10 years after an episode of drug induced liver injury, 23 [3.4%] had continuing liver disease, 8 with cirrhosis; none were attributed to a sulfonamide). 19155082
Gutierrez M, Filippucci E, Bugatti L, Bertolazzi C, Grassi W. [Severe drug hypersensitivity syndrome due to sulphasalazine in patient with rheumatoid arthritis]. Reumatismo 2009; 61: 65-8. Italian. PMID: 19370190 (60 year old man with rheumatoid arthritis developed rash, facial edema and fever 32 days after starting sulfasalazine [bilirubin normal, ALT 74 U/L, Alk P 142 U/L, 6% eosinophils], resolution with prednisone).
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: PMID: 2396-404. (313 cases of drug induced liver injury were seen over a 12 year period at a large hospital in Bangalore, India; dapsone accounted for 17 cases [5.4%] of which 2 were fatal, and TMP-SMZ accounted for 7 cases [2.2%], but none were fatal).
Lens S, Crespo G, Carrión JA, Miquel R, Navasa M. Severe acute hepatitis in the DRESS syndrome: Report of two cases. Ann Hepatol 2010; 9 (2): 198-201. (Two cases of DRESS syndrome; case 1, a 29 year old woman who developed fever, rash, eosinophilia, and jaundice 8 weeks after starting sulfasalazine [bilirubin 13.5 mg/dL, ALT 1117 U/L, Alk P 1171 U/L, INR 3.2] with signs of hepatic failure, but ultimate recovery on corticosteroids within 21 days; case 2 attributed to levetiracetam). 20526017
Khokhar OS, Lewis JH. Hepatotoxicity of agents used in the management of inflammatory bowel disease. Dig Dis 2010; 28: 508-18. (Review of liver toxicity of drugs for inflammatory bowel disease; sulfasalazine is cited as causing an acute hypersensitivity like reaction with fever, rash, and liver involvement, and both a granulomatous and a cholestatic form of liver injury and rarely acute liver failure). 20926880
Rogler G. Gastrointestinal and liver adverse effects of drugs used for treating IBD. Best Pract Res Clin Gastroenterol 2010; 24: 157-65. (Review of GI and liver side effects of drugs of inflammatory bowel disease; sulfasalazine is listed as causing “abnormal liver function” tests in 4% of patients). 20227029
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury including 12 due to sulfonamides [9%], 9 due to SMZ/TMP, and 3 due to sulfasalazine). 20949552
Anelli MG, Scioscia C, Grattagliano I, Lapadula G. Old and new antirheumatic drugs and the risk of hepatotoxicity. Ther Drug Monit 2012; 34: 622-8. (Review of liver injury caused by antirheumatic agents; sulfasalazine can cause liver injury in 1:1000 recipients, usually arising in the first month of treatment often with immunoallergic features and with typical signs of DRESS syndrome in some patients). 23128910
Descamps V. [Drug reaction with eosinophilia and systemic symptoms (DRESS)]. Rev Prat 2012; 62: 1347-52. French. PMID: 23424909 (Review of clinical features of DRESS syndrome in French).
Pirklbauer M, Gruber J. [DRESS syndrome following sulfasalazine treatment.]. Z Rheumatol. 2014; 73(2): 180-3. German. PMID: 24337150 (33 year old woman with juvenile idiopathic arthritis developed fever, rash, and dyspnea with cough 4 weeks after starting sulfasalazine [bilirubin not given, ALT 117 U/L, GGT 422 U/L], with pulmonary manifestations of DRESS syndrome, resolving with prednisone therapy).
Girelli F, Bernardi S, Gardelli L, Bassi B, Parente G, Dubini A, Serra L, et al. A new case of DRESS syndrome induced by sulfasalazine and triggered by amoxicillin. Case Rep Rheumatol 2013; 2013: 409152. (53 year old woman developed fever and lymphadenopathy 6 weeks after starting sulfasalazine for spondylitis, with subsequent rash and oral ulcers [bilirubin 2.7 mg/dL, ALT 350 U/L, Alk P 2959 U/L], improving with prednisone therapy). 23936716
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013; 144: 1419-25. (In a population-based study of drug induced liver injury from Iceland, 96 cases were identified over a 2-year period, including 2 that were attributed to TMP-SMZ). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, including 39 attributed to antimicrobial agents, but none to dapsone, sulfasalazine, or TMP/SMP). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 31 cases were attributed to TMP/SMZ and only 2 cases to dapsone). 25754159
Chalasani N, Reddy KRK, Fontana RJ, Barnhart H, Gu J, Hayashi PH, Ahmad J, et al. Idiosyncratic drug induced liver injury in African-Americans is associated with greater morbidity and mortality compared to Caucasians. Am J Gastroenterol 2017; 112: 1382-8. (Among 985 patients enrolled in a US prospective database of drug induced liver injury between 2004 and 2016, SMZ/TMP was the most implicated medication among 144 African Americans [7.6%], but ranked fifth among 841 Caucasians [3.6%] behind amoxicillin-clavulanate, nitrofurantoin, anabolic steroids and isoniazid). 28762375
Sussman S, Devlin V, Dimitriades VR. A teenager with sulfasalazine-associated dress syndrome after the introduction of amoxicillin. Clin Pediatr (Phila). 2017;56:290-291. (16 year old male with ulcerative colitis developed fever and abdominal pain 3 weeks after starting sulfasalazine was treated with amoxicillin and presented with rash, lymphadenopathy, and eosinophilia [800 cells/μL] and serum aminotransferase elevations [ALT 255 U/L] without jaundice one week later, symptoms and lab tests resolving with corticosteroids). 27356629
Liang J, Qu H, Wang X, Wang A, Liu L, Tu P, Li R, Wang M. Drug reaction with eosinophilia and systemic symptoms associated with reactivation of Epstein-Barr virus and/or cytomegalovirus leading to hemophagocytic syndrome in one of two patients. Ann Dermatol. 2018;30:71-74. (Two patients, 38 year old woman and 37 year old man, developed fever followed by pruritus 4 weeks after starting sulfasalazine and 3 weeks after starting a beta lactam antibiotic with ALT 212 and 123 U/L, bilirubin 1.4 mg/dL and normal, both with evidence of Ebstein Barr Virus reactivation). 29386835
Wu X, Yang F, Chen S, Xiong H, Zhu Q, Gao X, Xing Q, et al. Clinical, viral and genetic characteristics of drug reaction with eosinophilia and systemic symptoms (DRESS) in Shanghai, China. Acta Derm Venereol. 2018;98:401-405. (Between 2011 and 2016, 52 patients were seen with DRESS syndrome at a single referral center in Shanghai, all had rash and 83% had liver test abnormalities, and 10 with EBV DNA in serum; 18 due to allopurinol, 11 sulfasalazine, and 5 carbamazepine, 3 deaths; HLA-B*13:01 in 7 of 11 sulfasalazine cases [64% vs 15% of controls] and HLA-B*58:01 in all 18 allopurinol cases [100% vs 17% of controls]). 29242946
Jeimy S, McRae K, Pattani R. A 63-year-old returned traveler with fever, rash, hepatitis and eosinophilia. CMAJ. 2018;190:E831-E835. (63 year old woman with rheumatoid arthritis developed rash and fever 1 month after starting sulfasalazine [bilirubin 0.8 rising to 3.2 mg/dL, ALT 418 U/L, Alk P 402 U/L, eosinophils 1376/μL]) 29986859
Sil A, Bhattacharjee MS, Chandra A, Pramanik JD. Sulfasalazine-induced drug reaction with eosinophilia and systemic symptoms (DRESS) with concomitant acute chikungunya virus infection: possible role of new viral trigger. BMJ Case Rep. 2021;14:e244063. (30 year old Indian man developed fever and rash 2 months after starting sulfasalazine for joint pain was thought to have chikungunya virus infection but developed facial edema and lymphadenopathy with leukocytosis and eosinophilia [21%] and ALT elevation [190 U/L] and was treated with prednisone for suspected DRESS syndrome with gradual response and no relapse when corticosteroids were stopped). 34642219
Jayachandran M, Koshy V, David R, Santhakumari V, Padmanabhan DS, Surendran S, Tiwari A, et al. Adverse reaction profile of sulfasalazine and its persistence in chronic therapy of rheumatoid arthritis and spondyloarthritis: A multicentric observational study. Int J Clin Pharmacol Ther. 2022;60:327-335.. (Among 1114 patients with rheumatoid arthritis or spondyloarthritis being treated with sulfasalazine in one of 6 centers across India, 10% discontinued therapy because of adverse events including liver injury, usually during the first year of therapy: Abstract only). 35713159
Fontana RJ, Kleiner DE, Chalasani N, Bonkovsky H, Gu J, Barnhart H, Li YJ, et al. The impact of patient age and corticosteroids in patients with sulfonamide hepatotoxicity. Am J Gastroenterol. 2023;118:1566-1575.. (Among 105 cases of sulfonamide induced liver injury enrolled in a prospective U.S. database between 2004 and 2020, 93 were attributed to TMP-SMZ, 9 to sulfasalazine, 2 to dapsone, and 1 to sulfadiazine). 36848311
Kuchinskaya EM, Chikova IA, Kostik MM. Case report: sulfasalazine-induced hypersensitivity. Front Med (Lausanne). 2023;10:1140339. (12 year old girl with juvenile idiopathic arthritis developed fever and rash 17 days after starting sulfasalazine [bilirubin not given, ALT 150 rising to 1436 U/L, Alk P not given, eosinophil count not given] with leukocytosis, atypical lymphocytes, thrombocytopenia and ascites, responding to high dose methylprednisolone and subsequent gradual taper). 37293296
Chen VL, Rockey DC, Bjornsson ES, Barnhart H, Hoofnagle JH; Drug-Induced Liver Injury Network Investigators. Incidence of idiosyncratic drug-induced liver Injury caused by prescription drugs. Drug Saf. 2025;48:151-160. 39317916. (Analysis of 1284 cases of drug-induced liver injury enrolled in a U.S. prospective study, identified 11 cases [6%] attributed to sulfasalazine placing it in one of the top 25 agents causing liver injury and occurring at an estimated rate of 1 per 820 persons treated [95% CI = 1:370-1:1800]).
Bessone F, Hernandez N, Medina-Caliz I, García-Cortés M, Schinoni MI, Mendizabal M, Chiodi D, et al. Drug-induced liver injury in Latin America: 10-year experience of the Latin American DILI (LATINDILI) Network. Clin Gastroenterol Hepatol. 2025;23:89-102.. (Among 483 cases of drug-induced liver injury enrolled in a prospective Latin American database, only one was attributed to sulfasalazine [0.2%] while 12 cases [0.7%] were reported from a concurrent US database). 38992407
Karna NK, Osti A, Pokhrel G, Karna N, Thakur RK, Sigdel S. Concurrent acute interstitial nephritis with acute pyelonephritis in DRESS syndrome: a rare case report. Ann Med Surg (Lond). 2025;87:3925-3930. (19 year old Nepalese woman developed fever, rash, and facial edema 2 months after starting sulfasalazine for back pain and TMP/SMZ for urinary tract infections [peak bilirubin 2.3 mg/dL, ALT 1306 U/L, Alk P 196 U/L, eosinophilia 11%, serum albumin 2.0 g/dL, proteinuria 4 g/24 hours] responding to high dose methylprednisolone and tapering doses of corticosteroids with ultimate resolution of both the liver and renal abnormalities). 40486566
Andrews MB, Patrone MV, Bickston SJ. Drug reaction with eosinophilia and systemic symptoms (dress) syndrome following initiation of sulfasalazine for ulcerative colitis: a yearlong clinical challenge. Case Rep Gastrointest Med. 2025;2025:8870613. (34 year old African American woman with ulcerative colitis developed fever, generalized rash, facial edema, and lymphadenopathy 5 weeks after starting sulfasalazine [bilirubin 2.0 mg/dL, ALT 641 rising to 1847 U/L, Alk P 214 to 265 U/L, INR peak 1.8, peak eosinophils 3000/μL] responding to prednisone and cyclosporin but requiring high doses and relapsing repeatedly when drugs were tapered until 1 year after onset when she finally tolerated withdrawal without relapse). 40546655

## OTHER REFERENCE LINKS

1. Recent References on Sulfasalazine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=sulfasalazine/AE+AND+Human%5BMH%5D+AND+(jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI+OR+hepatitis,+toxic%5BMH%5D)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Sulfasalazine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=sulfasalazine)